# Loxapine

## OVERVIEW

### Introduction

Loxapine is a conventional antipsychotic used in the therapy of schizophrenia. Loxapine therapy is commonly associated with minor serum aminotransferase elevations and in very rare instances has been linked to clinically apparent acute liver injury.

### Background

Loxapine (lox' a peen) is a dibenzoxazepine tricyclic derivative which appears to act by blocking dopamine type 2 (D2) receptors. Loxapine has other central and peripheral effects including anticholinergic and α-adrenergic blockade. Loxapine is indicated for the therapy of psychotic disorders and was approved for this use in the United States in 1976. In recent years, loxapine has been replaced in large part by the atypical antipsychotics, which have fewer extrapyramidal side effects. Loxapine is available as tablets of 5, 10, 25 and 50 mg and in generic forms and previously under the brand name Loxitane. Recommended doses of oral loxapine are 10 mg twice daily initially, increasing to a maximum of 100 mg in divided doses daily. An aerosol formulation of loxapine has recently been developed (Adasuve) that is recommended for use in acute agitation in patients with bipolar disorder or schizophrenia. Common side effects include drowsiness, dizziness, headache, blurred vision, dry mouth, and tremor. Loxapine, unlike many antipsychotic agents, is not associated with significant weight gain. Rare, potentially severe adverse events of first generation antipsychotic agents may include increased mortality in elderly patients with dementia-related psychosis, tardive dyskinesia, neuroleptic malignant syndrome, orthostatic hypotension, falls and agranulocytosis.

### Hepatotoxicity

Liver test abnormalities have been reported to occur in a small proportion of patients on long term therapy with loxapine, but elevations are uncommonly above 3 times the upper limit of normal. The aminotransferase abnormalities are usually mild, asymptomatic and transient, reversing even with continuation of medication. Instances of clinically apparent acute liver injury have been reported due to loxapine and to the structurally related tricylic amoxapine (not available in the United States), but cases are rare. In reported cases, the onset of jaundice was within 4 to 8 weeks, and the pattern of serum enzyme elevations was typically hepatocellular. Immunoallergic features and autoantibody formation were not prominent. All cases were self-limited without fatalities or residual chronic liver injury.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which loxapine causes serum aminotransferase elevations is not known, but is likely due to production of a toxic intermediate by its metabolism. Loxapine is extensively metabolized by the liver via sulfoxidation and oxidation, partially via P450 system.

### Outcome and Management

The serum aminotransferase elevations that occur on loxapine therapy are usually self-limited and do not require dose modification or discontinuation of therapy. No instances of acute liver failure or vanishing bile duct syndrome due to loxapine have been reported. Patients with loxapine induced liver injury probably do not have cross sensitivity to atypical antipsychotics.

Drug Class: Antipsychotic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Loxapine – Generic, Loxitane®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Loxapine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Loxapine | 1977-10-2 | C18-H18-Cl-N3-O | Loxapine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 21 May 2019

Zimmerman HJ. Neuroleptic drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 483-91. (Expert review of hepatotoxicity of neuroleptic drugs including loxapine published in 1999, mentions that loxapine has been incriminated in cases of hepatic injury reported to the FDA, onset within first 3 weeks).
Larry D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of psychiatric agents; loxapine “..has been implicated in one case of hepatocellular injury...”).
Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
Clark ML, Huber WK, Sullivan J, Wood F, Costiloe JP. Evaluation of loxapine succinate in chronic schizophrenia. Dis Nerv Syst 1972; 33: 783-91. (Controlled trial comparing placebo, loxapine and chlorpromazine in 55 inpatients with schizophrenia; elevations in AST and Alk P occurred no more frequently with loxapine than placebo). 4589978
Heel RC, Brogden RN, Speight TM, Avery GS. Loxapine: a review of its pharmacological properties and therapeutic efficacy as an antipsychotic agent. Drugs 1978; 15: 198-217. (Review of structure, pharmacology, mechanism of action, efficacy and safety of loxapine; “Transient…abnormalities in liver function test values have been observed in a few patients, but did not appear to be clinically significant”). 25167
Reynolds PC, Som CW, Herrmann PW. Loxapine fatalities. Clin Toxicol 1979; 14: 181-5. (Two cases of suicidal overdose [2.5-2.9 grams] marked by coma, seizures and cardiovascular collapse within hours to days). 436393
Tam CW, Olin BR 3rd, Ruiz AE. Loxapine-associated rhabdomyolysis and acute renal failure. Arch Intern Med 1980; 140: 975-6. (22 year old man with suicidal loxapine overdose [~4 grams] developed rhabdomyolysis and acute renal failure; CPK 15,000 U/L and AST 54 U/L, but normal bilirubin and alkaline phosphatase). 6770772
DePaulo JR Jr, Ayd FJ Jr. Loxapine: fifteen years' clinical experience. Psychosomatics 1982; 23: 261-71. (“Hepatic… adverse effects with loxapine are extremely rare, but transitory fluctuations in…liver enzyme levels have occasionally been noted in clinical studies”). 7041162
Patterson JP. Amoxapine associated with hepatotoxicity. J Clin Psychopharmacol 1987; 7: 50-1. (38 year old man developed serum enzyme elevations 2 days after starting amoxapine which was continued for 24 days with enzymes rising to 30 days with tender liver, falling to normal thereafter; no specifics given). 3818992
Munyon WH, Salo R, Briones DF. Cytotoxic effects of neuroleptic drugs. Psychopharmacology (Berl) 1987; 91: 182-8. (In vitro testing for cytotoxicity found the phenothiazines to be the most, haloperidol intermediate and loxapine and molindone least toxic). 2883697
Manapany M, Marchetti B, Bertrand-Lepensec D, Lacroix G, Legré M. [Acute cytolytic hepatitis caused by amoxapine]. Gastroenterol Clin Biol 1993; 17: 405-6. (29 year old woman developed nausea and abdominal pain 18 days after starting amoxapine [bilirubin normal, ALT 736 U/L, Alk P 295 U/L], resolving within a month of stopping). 8349085
Allison DB, Mentore JL, Heo M, Chandler LP, Cappelleri JC, Infante MC, Weiden PJ. Antipsychotic-induced weight gain: a comprehensive research synthesis. Am J Psychiatry 1999; 156: 1686-96. (Systematic review of 81 articles on weight change with antipsychotics, using change after 10 weeks to compare agents: clozapine +5.7, olanzapine +4.2, chlorpromazine +4.2, quetiapine +2.5, risperidone +1.7, loxapine +0.6, haloperidol +0.5, ziprasidone +0.3, molindone -0.1, and pimozide -2.7 kg). 10553730
Chakrabarti A, Bagnall A, Chue P, Fenton M, Palaniswamy V, Wong W, Xia J. Loxapine for schizophrenia. Cochrane Database Syst Rev 2007; (4): CD001943. (Cochrane review of efficacy and safety of loxapine; no mention of ALT elevations or hepatic side effects). 17943763
Torrent C, Amann B, Sanchez-Moreno J, Colom F, Feinares M, Comes M, Rosa AR, et al. Weight gain in bipolar disorder: pharmacological treatment as a contributing factor. Acta Psychiatr Scand 2008; 118: 4-18. (Review of frequency of weight gain in patients treated for bipolar disorders, most weight gain occurred with clozapine and olanzapine, but some weight gain also with quetiapine, risperidone, lithium, valproate and gabapentin; little or none with molindone, loxapine, carbamazepine and lamotrigine). 18498432
Allen MH, Feifel D, Lesem MD, Zimbroff DL, Ross R, Munzar P, Spyker DA, et al. Efficacy and safety of loxapine for inhalation in the treatment of agitation in patients with schizophrenia: a randomized, double-blind, placebo-controlled trial. J Clin Psychiatry 2011; 72: 1313-21. (Controlled trial of inhaled loxapine in 129 patients with acute agitation and schizophrenia; side effects included dysgeusia, dizziness, and local irritation; no mention of hepatotoxicity). 21294997
Kwentus J, Riesenberg RA, Marandi M, Manning RA, Allen MH, Fishman RS, Spyker DA, et al. Rapid acute treatment of agitation in patients with bipolar I disorder: a multicenter, randomized, placebo-controlled clinical trial with inhaled loxapine. Bipolar Disord 2012; 14: 31-40. (Controlled trial of inhaled loxapine 314 patients with acute agitation and bipolar disorder; no serious adverse events or mention of liver injury). 22329470
Currier G, Walsh P. Safety and efficacy review of inhaled loxapine for treatment of agitation. Clin Schizophr Relat Psychoses 2013; 7: 25-32. (Review of the safety and efficacy of inhaled loxapine). 23538290
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to loxapine or other antipsychotic medications). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, five were attributed to atypical antipsychotics [3 quetiapine, 2 olanzapine], but none to loxapine). 25754159
Drugs for psychotic disorders. Med Lett Drugs Ther 2016; 58 (1510): 160-4. (Concise review of medications available in the US for therapy of psychotic disorders; mentions that loxapine is a first generation agent and generically available, but does not discuss loxapine individually or mention ALT elevations or hepatotoxicity for any of the agents discussed) 27960194

## OTHER REFERENCE LINKS

1. Recent References on Loxapine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Loxapine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Loxapine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Loxapine)